# Cinnamon

## OVERVIEW

### Introduction

Cinnamon is a spice derived from the inner bark of the Cinnamonium tree that is native to Sri Lanka, India, and South Asia and which has been used in traditional Indian and Chinese medicine for a variety of conditions including digestive symptoms, headache, fever, amenorrhea, and more recently diabetes, hypercholesterolemia, and hypertension. Cinnamon used as an herbal medicine is generally well tolerated but has been implicated in isolated, rare reports of acute liver injury.

### Background

Cinnamon is an extract of the inner bark of Cinnamonium species of trees including C. verum (or “true cinnamon” from Sri Lanka), C. cassia (from China), C. burmanii, and C. loureiroi found in South Asia. Cinnamon is a spice that is commonly used in cooking and found in many foods. As a medication, cinnamon has been used in Indian (Ayurvedic) and Chinese traditional medicine to treat a variety of conditions, including gastrointestinal complaints, flatulence, vaginitis, amenorrhea, impotence, headache, toothache, fever, rheumatism and neuralgia. Chemical analyses demonstrate multiple constituents in cinnamon preparations, the main ingredient being cinnamaldehyde with lesser amounts of eugenol, cinnamyl acetate, cinnamyl alcohol, cinnamic acid, proanthocyanidins, and coumarin. In vitro studies suggest that cinnamon has antimicrobial, antioxidant, antitumor, antilipidemic, antidiabetic, antihypertensive, and immunomodulatory effects. Several laboratory, animal, and human clinical studies have suggested that cinnamon might have effects in lowering fasting glucose levels and improving Hgb A1c levels in patients with type 2 diabetes and improving blood pressure in patients with hypertension. However, properly controlled prospective controlled trials have yielded conflicting results, and cinnamon is not approved for any medical condition in the United States. In Europe, cinnamon is approved for therapy of dyspepsia and loss of appetite. Cinnamon is available in multiple forms including powders, tablets, soft gels, capsules, and teas. The typical dose is 1 to 2 g daily. In clinical trials of various preparations and dosages of cinnamon there have been no consistently reported adverse effects or reported instances of hypersensitivity. Occasionally, more serious adverse events have been attributed to the presence of coumarin in cinnamon preparations. However, the concentration of coumarin varies greatly in different preparations and minimal or only low concentrations are found in C. verum and C. cassia.

### Hepatotoxicity

Cinnamon has not been subjected to large, prospective trials of its safety but is widely described as being well tolerated, without side effects, or with only minor gastrointestinal complaints or rash that rarely require dose adjustment or discontinuation. In small clinical trials of cinnamon in diabetes, there have been no reports of serum aminotransferase or bilirubin elevations or instances of clinically apparent liver injury. Cinnamon is not mentioned or listed in large case series or systematic reviews of the literature on herbal and dietary supplement induced liver injury. Nevertheless, at least 3 cases of acute liver injury attributed to cinnamon have been published including publications from the United States, Japan, and the Middle East. In published reports, none included rechallenge, and in some cases, other diagnoses were possible, if not more likely. Thus, there remains uncertainty whether cinnamon even in high medicinal doses can result in liver injury.

Likelihood score: D (possible rare cause of clinically apparent liver injury).

### Mechanism of Injury

Despite wide-scale use, cinnamon has been linked to only rare and not completely convincing instances of clinically apparent liver injury. The mechanism by which cinnamon might cause liver injury is not known but is possibly related to the presence of coumarin in cinnamon preparations. Coumarin when used as an anticoagulant or as treatment for lymphedema after breast cancer surgery was implicated in many cases of acute hepatocellular liver injury (see LiverTox chapter on warfarin).

Drug Class: Herbal and Dietary Supplements

Other names: Ceylon Cinnamon

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Cinnamon – Generic

DRUG CLASS

Herbal and Dietary Supplements

SUMMARY INFORMATION

Fact Sheet at National Center for Complementary and Integrative Health, NIH (https://www.nccih.nih.gov/health/cinnamon)

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Cinnamaldehyde | 14371-10-9 | C9H8O | 403032621
Coumarin | 91-64-5 | C9H6O2 | 403032568

## ANNOTATED BIBLIOGRAPHY

References updated: 01 July 2026

Abbreviations: HDS, herbal and dietary supplements; ULN, upper limit of normal; HbA1c, hemoglobin A1c; UHPLC-HRMS, Ultra-high performance liquid chromatography and high resolution mass spectroscopy.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications are discussed, but not cinnamon).
Liu LU, Schiano TD. Hepatotoxicity of herbal medicines, vitamins and natural hepatotoxins. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 2nd ed. New York: Informa Healthcare USA, 2007, pp. 733-54. (Review of hepatotoxicity of herbal and dietary supplements [HDS] published in 2007; no mention of cinnamon).
Cinnamon. In, PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007: pp. 197-198. (Compilation of short monographs on herbal medications and dietary supplements; mentions that cinnamon is indigenous to Sri Lanka and southwest India and consists of the dried inner tree bark, and that it is approved by the European Commission E as treatment for loss of appetite and dyspeptic complaints; no mention of its use in diabetes or side effects of ALT elevations or hepatoxicity).
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbals in a Swedish Registry does not list cinnamon among products associated with 5 or more reports). 19650152
Casley-Smith JR, Casley-Smith JR. Frequency of coumarin hepatotoxicity. Med J Aust. 1995;162:391. PMID: (Summary of hepatotoxicity from coumarin by members of the Lymphoedema Association of Australia; among 1106 patients in 7 clinical trials of coumarin for an average of 14.6 months, 2 developed jaundice, one of whom required liver transplantation; since licensure, 4 of an estimated 1750 exposed patients were reported with hepatotoxicity suggesting a rate of ~0.2%). 7715532
Loprinzi CL, Sloan J, Kugler J. Coumarin-induced hepatotoxicity. J Clin Oncol. 1997;15:3167–8. PMID: (Among 138 patients enrolled in a controlled trial of coumarin [5,6-benzo-a-pyrone, not an anticoagulant] for breast cancer, 6 developed hepatotoxicity [9% on active drug], 5 with asymptomatic AST elevations and one with clinically apparent liver injury and jaundice [bilirubin 19.5 mg/dL, AST 2315 U/L, Alk P 214 U/L], 2 months after starting and resolving within 3 months of stopping). 9294482
Ghosh P, Markin RS, Sorrell MF. Coumarin-induced hepatic necrosis. Am J Gastroenterol. 1997;92:348–9. PMID: (66 year old man developed jaundice 3 months after starting experimental therapy with coumarin for prostate cancer [bilirubin 4.6 mg/dL, ALT 1094 U/L], but it was continued until 15 weeks when he was deeply jaundiced [bilirubin 13.9 mg/dL, ALT 936 UL, Alk P 292 U/L], resolving within 9 weeks of stopping). 9040223
Koch S, Beurton I, Bresson-Hadni S, Monnot B, Hrusovsky S, Becker MC, Vanlemmens C, et al. Gastroenterol Clin Biol. 1997;21:223–5. [Acute cytolytic hepatitis caused by coumarin. 2 cases] French. PMID: 9161499 (Two women, ages 40 and 45 years, developed jaundice and pruritus 5 months after starting coumarin for lymphedema [bilirubin 5.8 and 25.1 mg/dL, ALT 30 and 100 times ULN, Alk P normal], resolving within 2 months of stopping; one was restarted on coumarin and redeveloped jaundice within 3 weeks).
Abraham K, Wöhrlin F, Lindtner O, Heinemeyer G, Lampen A. Toxicology and risk assessment of coumarin: focus on human data. Mol Nutr Food Res. 2010;54:228-39. PMID: (The tolerable daily dose of coumarin derived from studies in humans according to the European Food Safety Authority is 0.1 mg/kg, an amount that can be exceeded in humans eating cinnamon spiced Christmas cookies during the holidays). 20024932
Wainstein J, Stern N, Heller S, Boaz M. Dietary cinnamon supplementation and changes in systolic blood pressure in subjects with type 2 diabetes. J Med Food. 2011;14:1505-10. PMID: (Among 59 adults with type 2 diabetes treated with cinnamon [800 mg] or placebo 3 times daily for 12 weeks, there were no significant differences in change in blood pressure, glycemic control or lipid levels between the two groups; no mention of adverse events, ALT levels or hepatotoxicity). 21861719
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs and herbal supplements but does not mention or list cinnamon). 22928722
Ranasinghe P, Pigera S, Premakumara GA, Galappaththy P, Constantine GR, Katulanda P. Medicinal properties of 'true' cinnamon (Cinnamomum zeylanicum): a systematic review. BMC Complement Altern Med. 2013;13:275. PMID: (Systematic review of literature on “medicinal benefits of C. zeylanicum”, largely from in cell culture studies and animal models, found evidence of antimicrobial, anti-oxidant, anti-inflammatory, anti-hypertensive, lipid lowering and wound healing effects and “studies reported minimal toxic and adverse events”; no mention of ALT elevations or hepatotoxicity in the few human studies included.). 24148965
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 839 cases of liver injury from drugs collected in the US between 2004 and 2013, 130 were due to HDS products, including 45 from body building agents [probably anabolic steroids] and 85 from diverse HDS products, but no case was attributed to cinnamon). 25043597
Medagama AB, Bandara R. The use of complementary and alternative medicines (CAMs) in the treatment of diabetes mellitus: is continued use safe and effective? Nutr J. 2014;13:102. PMID: (Review of the safety and efficacy of popular herbal products used in treating diabetes including cinnamon, bitter gourd, and fenugreek mentions that studies in vitro suggest that cinnamon causes an increase in glucose entry into cells, but controlled trials in humans have had mixed results some showing no effect on fasting glucose or Hgb A1c levels compared to placebo). 25331834
Brancheau D, Patel B, Zughaib M. Do cinnamon supplements cause acute hepatitis? Am J Case Rep. 2015;16:250-4. PMID: (73 year old woman developed vomiting and abdominal pain 1 week after starting cinnamon supplements [unknown dose and species] for diabetes [bilirubin 0.4 mg/dL, ALT 550 U/L, AST 927 U/L, Alk P 245 U/L, GGT 181 U/L] with rapid resolution after stopping and no recurrence on restarting her chronically used conventional medications). 25923145
Brown AC. Liver toxicity related to herbs and dietary supplements: online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products does not list or discuss cinnamon). 27402097
Higaki H, Onji M, Takeji S, Uehara T, Kawasaki K, Kashimoto Y, Murakami T, et al. A case of severe drug-induced liver injury caused by over the counter herb (cinnamon): review of literature. Euroasian J Hepatogastroenterol. 2018;8:167-171. PMID: (40 year old man developed fatigue and abdominal pain followed by dark urine and jaundice 1 to 3 months after starting two Chinese herbal supplements both of which contained cinnamon and fennel [bilirubin 11.9 mg/dL, ALT 847 U/L, AST 988 U/L, Alk P 320 U/L, prothrombin time 58%], imaging showing a “potato-like liver”, and with slow recovery and one relapse weeks after stopping the supplements). 30828560
Hajimonfarednejad M, Nimrouzi M, Heydari M, Zarshenas MM, Raee MJ, Jahromi BN. Insulin resistance improvement by cinnamon powder in polycystic ovary syndrome: A randomized double-blind placebo controlled clinical trial. Phytother Res. 2018;32:276-283. PMID: (Among 66 women with polycystic ovary syndrome on progesterone therapy who were treated with the addition of cinnamon [1.5 g] or placebo once daily for 12 weeks, improvements in body weight, glycemic indices, and lipids were similar in the two groups and the only adverse event was rash in one patient which resolved on stopping cinnamon; no mention of ALT levels or hepatotoxicity). 29250843
Zare R, Nadjarzadeh A, Zarshenas MM, Shams M, Heydari M. Efficacy of cinnamon in patients with type II diabetes mellitus: A randomized controlled clinical trial. Clin Nutr. 2019;38:549-556. PMID: (Among 138 adults with diabetes treated with cinnamon [500 mg] or placebo twice daily for 3 months, body weight, fasting glucose, HgbA1c, and cholesterol levels improved more with cinnamon than placebo, and “no patients reported any adverse event in the cinnamon group”; no mention of ALT levels or hepatotoxicity). 29605574
Wang Y, Harrington PB, Chen P. Metabolomic profiling and comparison of major cinnamon species using UHPLC-HRMS. Anal Bioanal Chem. 2020;412:7669-7681. PMID: (Chemical analyses of 4 commonly used species of cinnamon found major differences in concentration of some of the 36 metabolites identified, high levels of coumarin being found in 2 species, but only low levels in one [cassia: Chinese] and minimal levels in another [verum: Sri Lankan] suggesting that there may be differences in efficacy and safety between different types of cinnamon). 32875369
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90], Herbalife products [64], kava [62], and greater celandine [48]; cinnamon is not listed). 34307603
Yesukumar SJ, Bakir L, Mohamed IA, Danjuma M. Probable cinnamon-induced mixed hepatocellular-cholestatic liver injury in a young woman: a case report. Cureus. 2025;17:e93328. PMID: (34 year old woman developed nausea and abdominal pain followed by dark urine and jaundice after doubling her long-term daily intake of cinnamon boiled in water [bilirubin 2.0 mg/dL, ALT 506 U/L, AST 329 U/L, Alk P 261 U/L] with worsening for a few days after stopping and then rapid improvement and normal liver test results 1 month later). 41158894

## OTHER REFERENCE LINKS

1. Recent References on Cinnamon: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Cinnamon+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

2. Trials on Cinnamon: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=cinnamon)